# Triamterene

## OVERVIEW

### Introduction

Triamterene is a potassium-sparing diuretic widely used in the therapy of edema. Triamterene has been linked to rare cases of clinically apparent drug induced liver disease.

### Background

Triamterene (trye am' ter een) is an inhibitor of renal epithelial sodium channels in the late distal tubule and collecting ducts of the kidney. As a result, triamterene promotes a mild sodium diuresis, but maintains body potassium levels. Triamterene is used largely in therapy of edema and can be safely used in patients with cirrhosis. Because of its potassium-sparing actions, triamterene is also used in combination with thiazide or loop diuretics in an attempt to prevent hypokalemia. Triamterene was approved for use in the United States in 1964 and continues to be widely used with more than 20 million prescriptions filled yearly. Triamterene is available in tablets and capsules of 50 and 100 mg in generic forms and under the brand name of Dyrenium. The typical dose of triamterene is 50 to 200 mg daily in one or two divided doses. Triamterene is also available in fixed dose combinations with hydrochlorothiazide (Maxide, Dyazide and generically). Triamterene is usually well tolerated but side effects can include dizziness, fatigue, headache, dry mouth, hyperkalemia and dehydration. Rare but potentially severe adverse events include rash, photosensitivity, and anaphylaxis.

### Hepatotoxicity

Triamterene therapy has been associated with rare instances of idiosyncratic, clinically apparent liver injury which have invariably been mild and anicteric. The liver injury typically arises after 4 to 12 weeks of therapy and the pattern of serum enzyme elevations is usually hepatocellular or mixed. Fever is a prominent symptom and the reaction is often more typical of drug-fever than hepatotoxicity (Case 1). Rash and eosinophilia can occur, but are usually not prominent. Autoantibodies are rare. All published cases of triamterene associated liver injury have been self-limited in course and resolved rapidly upon withdrawal.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of triamterene hepatic injury is unknown, but it likely to be due to hypersensitivity.

### Outcome and Management

Most instances of triamterene associated liver injury have been mild and rapidly reversible upon drug withdrawal. Rapid recurrence upon rechallenge has been reported. There is no evidence of cross reactivity to the hepatic injury with other diuretics.

Drug Class: Diuretics, Potassium-Sparing Diuretics

Other Drugs in the Subclass: Amiloride, Eplerenone, Spironolactone

## CASE REPORT

### Case 1. Triamterene induced fever and liver injury.(1)

A 44 year old woman developed fever, malaise and right upper quadrant pain one month after starting triamterene (100 mg daily) for peripheral edema. On examination, she was febrile (39^o^ C) and had hepatic tenderness, but no rash or lymphadenopathy. Laboratory tests showed elevations in serum enzymes with AST 428 U/L and Alk P 170 U/L and slightly elevated total white blood cell count (12,000/µL). Abdominal ultrasound showed fatty liver, but no evidence of biliary obstruction. Serum bilirubin levels, prothrombin time, hepatitis A or B markers and autoantibodies were not mentioned. Triamterene was stopped and her fever abated. She was discharged but presented 1 day later with recurrence of symptoms and fever. The white blood cell count was again raised and was accompanied by eosinophilia (2,520/µL). Serum enzymes were more elevated than before. Careful history revealed that she had restarted triamterene six hours before the reappearance of fever. Withholding further triamterene therapy was followed by resolution of fever and fall of white count and liver test abnormalities to normal levels within 6 days.

#### Key Points

Medication: | Triamterene (100 mg daily)
Pattern: | Hepatocellular (R=6.8)
Severity: | Mild (enzyme elevations without jaundice)
Latency: | 1 month initially, 1 day on rechallenge
Recovery: | 1-2 weeks
Other medications: | None

#### Comment

This patient developed drug fever one month after starting triamterene and had an accompanying increase in liver enzyme values. Rechallenge let to a prompt recurrence. These features were compatible with a hypersensitivity reaction with minor hepatic involvement. While rash and drug fever have been described with triamterene therapy, acute liver injury with jaundice has not.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Triamterene – Generic, Dyrenium®

DRUG CLASS

Diuretics

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Triamterene)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Triamterene | 396-01-0 | C12-H11-N7

## CITED REFERENCES

1 Nolan PJ, D’Arcy G. (1987). Triamterene drug fever and hepatitis. Med J Aust.

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2021

Zimmerman HJ. Diuretic drugs. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 662-4. (Expert review of hepatotoxicity of diuretics published in 1999 mentions that clinically apparent liver injury due to diuretics is rare; hepatocellular jaundice has been reported with triamterene).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular agents, mentions that thiazide diuretics can rarely cause cholestatic hepatitis; no mention of potassium sparing diuretics).
Jackson EK. Drugs affecting renal excretory function. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 445-70. (Textbook of pharmacology and therapeutics).
Safdi MA. (1980). Fever secondary to triamterene therapy. N Engl J Med. (53 year old woman with alcoholic liver disease developed fever 10 days after starting triamterene and hydrochlorothiazide, resolving within 3 days of stopping and recurring twice with rechallenge using triamterene alone; no evidence of worsening of liver test abnormalities).
Nolan PJ, D’Arcy G. (1987). Triamterene drug fever and hepatitis. Med J Aust. (44 year old woman developed fever, abdominal pain and anorexia ~3 weeks after starting triamterene [AST 428 U/L, Alk P 170 U/L, bilirubin not mentioned], resolving within days upon withdrawal with abrupt recurrence with eosinophilia upon restarting: Case 1, triamterene).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 137 [0.5%] were done for idiosyncratic drug induced acute liver failure, none were attributed to a diuretic).
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al. (2005). Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology. (Reports of drug induced liver injury to a Spanish network found 570 cases; diuretics not mentioned as cause).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports [89% from the US]; no diuretic found in the 20 most commonly implicated agents).
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. (2007). Risk of acute liver injury associated with the use of drugs: a multicentre population survey. Aliment Pharmacol Ther. (Population based survey of 126 cases of acute liver injury [24 with acute liver failure] due to drugs between 1993-1999 in Spain calculated relative risk of injury compared to the general population: hydrochlorothiazide was being taken by 7 and furosemide by 8 patients, but relative risk was not increased in comparison to a control group).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no case was attributed to a diuretic).
(2009). Drugs for hypertension. Treat Guidel Med Lett. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities: “thiazide diuretics are the first-line therapy for many patients with hypertension”).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, none were attributed to a diuretic).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, no diuretic was mentioned among the 30 most common causes of liver injury).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which none were attributed to a diuretic).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to a diuretic).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to a diuretic).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to a diuretic).
(2020). Drugs for hypertension. Med Lett Drugs Ther. (Concise summary of efficacy, safety and costs of drug therapy of hypertension including the diuretics, focusing upon relative usefulness; no mention of hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Triamterene: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Triamterene/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Triamterene: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Triamterene)